# Minoxidil

## OVERVIEW

### Introduction

Minoxidil is an antihypertensive agent that is used largely for patients with severe and refractory hypertension not responding to conventional therapies. Minoxidil is also used topically to treat male pattern baldness. Despite its use for many years, minoxidil has not been convincingly linked to cases of clinically apparent liver injury.

### Background

Minoxidil (min ox' i dil) is one of the first antihypertensive agents developed for use in humans. Minoxidil is activated in the liver and acts to relax vascular smooth muscle by opening cell surface potassium channels causing an efflux of potassium, hyperpolarization and relaxation of smooth muscle cells. The increased vasodilation caused by minoxidil can result in a reflex increase in cardiac output and sodium retention for which reasons it is not recommended as monotherapy or as a first line agent for hypertension. Minoxidil was approved for use in the United States in 1979 and continues to be used for treatment of severe and refractory hypertension, usually in combination with beta blockers and diuretics. Minoxidil is available in tablets of 2.5 and 10 mg in generic forms and under the brand name Loniten. The usual initial dose in adults is 2.5 to 5 mg once daily, with subsequent adjustment based upon tolerance and clinical effect to a typical maintenance dose is 10 to 40 mg daily. Minoxidil has many side effects including sodium retention, edema, headache, nausea, breast tenderness, gynecomastia, hypertrichosis and rash. The effect on hair growth has led to the use of topical minoxidil to treat male pattern baldness. Various topical forms of minoxidil (solutions, foams) with concentrations of 2% to 7% are available by prescription and over-the counter for hair growth, both in women and in men. These solutions have minor local side effects but systemic absorption is minimal.

### Hepatotoxicity

Serum aminotransferase elevations during oral minoxidil therapy are uncommon, but have been reported even with topical administration. Despite many decades of use, oral minoxidil has not been implicated in convincing cases of clinically apparent acute liver injury. Severe rash, toxic epidermal necrolysis and Stevens Johnson syndrome have been reported after minoxidil therapy (generally arising within 2 to 6 weeks of starting), but published cases have not been marked by concurrent hepatic injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Minoxidil is metabolized by the liver, but has little effect on hepatic metabolism of other drugs. The reason for its lack of hepatotoxicity is not known.

Drug Class: Antihypertensive Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Minoxidil – Generic, Loniten®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Minoxidil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Minoxidil | 38304-91-5 | C9-H15-N5-O

## ANNOTATED BIBLIOGRAPHY

References updated: 28 January 2020

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-71. (Expert review of hepatotoxicity published in 1999; mentions that topical minoxidil has been associated with liver injury).
De Marzio DH, Navarro VJ. Antihypertensives. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-5. (Review of hepatotoxicity of antihypertensive drugs, minoxidil is not discussed).
Eschenhagen T. Treatment of hypertension. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 507-26. (Textbook of pharmacology and therapeutics; minoxidil is metabolized in the liver to its active molecule, which relaxes vascular smooth muscle by activating the ATP-modulated potassium channel).
DiSantis DJ, Flanagan J. (1981). Minoxidil-induced Stevens-Johnson syndrome. Arch Intern Med. (35 year old man developed rash 17 days after starting minoxidil and 12 days after starting allopurinol followed by fever and desquamation, improving on stopping and with corticosteroids; on restarting minoxidil he developed rash and fever 3 days later; no mention of liver involvement).
Colamarino R, Dubost JJ, Sauvezie B. (1990). Polymyalgia and minoxidil. Ann Intern Med. (4 men, ages 27-48 years, developed fatigue, muscle aches, anorexia and low grade fever 2 to 14 months after starting topical minoxidil, 3 had transient liver enzyme elevations, but none had jaundice and abnormalities resolved rapidly upon withdrawal).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antihypertensive agents accounted for 5% of cases and included methyldopa, irbesartan, amlodipine, lisinopril and hydralazine; no case was attributed to minoxidil).
Levi N, Bastuji-Garin S, Mockenhaupt M, Roujeau JC, Flahault A, Kelly JP, Martin E, et al. (2009). Medications as risk factors of Stevens-Johnson syndrome and toxic epidermal necrolysis in children: a pooled analysis. Pediatrics. (Pooled analysis of 80 cases of Stevens Johnson syndrome in children from 2 multicenter international case control studies did not confirm an association with medication use).
Callen EC, Church CO, Hernandez CL, Thompson ED. (2007). Stevens-Johnson syndrome associated with oral minoxidil: a case report. J Nephrol. (50 year old man developed oral blisters 1 week after starting minoxidil; liver tests were normal).
Karaoui LR, Chahine-Chakhtoura C. (2009). Fatal toxic epidermal necrolysis associated with minoxidil. Pharmacotherapy. (69 year old woman developed severe rash 11 days after starting minoxidil with bullae and death 2 weeks later; liver tests were normal on admission).
(2009). Drugs for hypertension. Treat Guidel Med Lett. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities; minoxidil is considered a direct vasodilator and should be given with a beta blocker or centrally acting drug to minimize reflex increase in heart rate and diuretic to avoid sodium retention; it can also cause hirsutism).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to minoxidil).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to minoxidil).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. PMID: 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4.3%] were attributed to antihypertensive agents, but none specifically to minoxidil).
(2015). Topical minoxidil: accidental poisoning in children. Prescrire Int. (2 year old girl swallowed 100 mg of minoxidil contained in her father’s 2% solution for hair growth, and developed flushing, nausea, tachycardia and hypotension requiring specific interventions, ultimately resolving; no mention of liver injury).
(2017). Drugs for hypertension. Med Lett Drugs Ther. (Concise review of the mechanisms of action, clinical efficacy, toxicities and costs of drugs for hypertension reports that minoxidil is very potent and rarely failing to lower blood pressure, but currently reserved for severe and refractory cases of hypertension, side effects being hirsutism, tachycardia and fluid retention; no mention of ALT elevations or hepatotoxicity).
Kassai B, Bouyé P, Gilbert-Dussardier B, Godart F, Thambo JB, Rossi M, Cochat P, et al. (2019). Minoxidil versus placebo in the treatment of arterial wall hypertrophy in children with Williams Beuren Syndrome: a randomized controlled trial. BMC Pediatr. (Among 17 children with Williams Beuren Syndrome treated with minoxidil or placebo for 18 months, there were no severe adverse events; ALT elevations and hepatotoxicity were not mentioned).
Jimenez-Cauhe J, Saceda-Corralo D, Rodrigues-Barata R, Hermosa-Gelbard A, Moreno-Arrones OM, Fernandez-Nieto D, Vaño-Galvan S. (2019). Effectiveness and safety of low-dose oral minoxidil in male androgenetic alopecia. J Am Acad Dermatol. (Retrospective analysis of 41 men treated with low dose minoxidil for 6 months found no serious adverse events; no mention of ALT elevations or hepatotoxicity).
Blume-Peytavi U, Issiakhem Z, Gautier S, Kottner J, Wigger-Alberti W, Fischer T, Hoffmann R, et al. (2019). Efficacy and safety of a new 5% minoxidil formulation in male androgenetic alopecia: A randomized, placebo-controlled, double-blind, noninferiority study. J Cosmet Dermatol. (220 men with male pattern baldness were treated with 2 formulations of 5% minoxidil or placebo topical applications to the scalp twice daily for 16 weeks, adverse events included pruritus [3.2%], skin burning [1.4%] and exfoliation [1.4%] but no serious adverse events occurred; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Minoxidil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Minoxidil/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Minoxidil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Minoxidil)